# Carbamazepine

## OVERVIEW

### Introduction

Carbamazepine is an aromatic anticonvulsant that is widely used in therapy of epilepsy and trigeminal neuralgia and is a well established cause of clinically apparent liver injury which can be severe and even fatal.

### Background

Carbamazepine (kar" ba maz' e peen) is an iminostilbene that is chemically related to tricyclic antidepressants and unrelated in structure to other anticonvulsants. Carbamazepine suppresses spread of seizure activity by reduction in the post-tetanic potentiation of synaptic transmission. Carbamazepine was approved for use in epilepsy in the United States in 1968 and it is still in common use with more than 2 million prescriptions being written yearly. Current indications include prevention and management of partial, complex, mixed and generalized seizures. It is used alone or in combination with other anticonvulsants. Carbamazepine is also effective in trigeminal neuralgia and peripheral neuropathies, but the mechanisms of its analgesic actions are not known. Carbamazepine is used off label for behavioral disorders and depression. Tablets of 100 mg and 200 mg and extended release capsules of 100, 200 and 400 mg are available, as are liquid formations and chewable forms for use in pediatrics. Carbamazepine is available in multiple generic forms and under the commercial names as Tegretol, Carbatrol, Equetro and Epitol. The recommended starting dose in adults for seizures is 200 mg twice daily or 100 mg four times daily, with increase in dose by 100 to 200 mg at weekly intervals based upon clinical response, but generally not exceeding 1200 mg daily. Doses in children are based upon body weight. Typically, lower doses are used for trigeminal neuralgia and other less established indications (restless leg syndrome, bipolar disorders, chorea). Frequent side effects include drowsiness, sedation, ataxia, blurred vision, nausea, vomiting, and skin rash.

### Hepatotoxicity

Prospective studies indicate that a sizeable proportion of patients taking carbamazepine have transient serum aminotransferase elevations (ranging from 1% to 22%). These elevations are usually benign, not associated with liver histological abnormalities and usually resolve even with drug continuation. In addition, most patients on carbamazepine develop mild-to-moderate elevations in gamma glutamyltranspeptidase (GGT) levels, probably indicative of hepatic enzyme induction rather than liver injury. Marked aminotransferase elevations (more than 5 fold elevated) occur less frequently.

Clinically apparent hepatotoxicity from carbamazepine is uncommon but well described, there being several hundred cases reported in the literature. Carbamazepine hepatotoxicity most often occurs in the setting of anticonvulsant hypersensitivity syndrome with onset of fever, followed by rash, facial edema, lymphadenopathy, elevations in white count and eosinophilia or atypical lymphocytosis, 1 to 8 weeks after starting therapy (Case 1 and 2). This syndrome is usually referred to as Drug Rash with Eosinophilia and Systemic Symptoms [DRESS]. The most frequent form of systemic involvement in DRESS syndrome is liver injury. The liver involvement ranges from mild and transient elevations in serum enzymes to abrupt onset of an acute hepatitis-like syndrome that can be severe and even fatal. However, the most common pattern of enzyme elevations in carbamazepine related DRESS syndrome is a mixed or cholestatic injury. Liver biopsy shows the cholestatic injury with focal hepatocellular necrosis, prominence of eosinophils and occasionally granulomas. In fatal cases, liver histology also shows bridging, submassive or massive necrosis. Other systemic involvement in carbamazepine induced DRESS syndrome includes myositis, nephritis and pneumonitis. Carbamazepine induced DRESS syndrome has also been linked to several cases of vanishing bile duct syndrome in which a severe cholestatic hepatitis with immunoallergic features is followed by persistence of cholestasis with itching, jaundice and prominent elevations in alkaline phosphatase levels. In most instances, vanishing bile duct syndrome gradually improves with time, but some instances are severe and unremitting, leading eventually to end stage liver disease and death or need for liver transplantation several months or even years fter onset (Case 3).

Carbamazepine hepatotoxicity can also occur without immunoallergic features in which case the latency to onset can be as long as 6 to 12 months after starting. The cases of carbamazepine liver injury without immunoallergic features tend to be hepatocellular rather than cholestatic or mixed and are more likely to be severe (Case 4). Carbamazepine is a commonly listed agent in case series of acute liver failure.

Likelihood score: A (Well established cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of carbamazepine hepatotoxicity appears to be hypersensitivity or an immunological response to a metabolically generated drug-protein complex. Carbamzapine associated severe cutaneous adverse events (Stevens Johnson syndrome and toxic epidermal necrosis) have been linked to HLA-B*1502 in Southeast Asian populations. In European, Korean and Japanese populations this association is not found, but in whom there is a less stong association with HLA-A*3101 and carbamazepine induced hypersensitivity reactions. The association of liver injury with these HLA haplotypes has been less well demonstrated. Carbamazepine, like other aromatic anticonvulsants, can also trigger acute porphyria by inducing delta aminolevulinic acid (ALA) synthetase activity.

### Outcome and Management

Carbamazepine hepatotoxicity is usually rapidly reversible with stopping therapy, improvements beginning within 5 to 7 days. In cases of severe injury, progression to acute liver failure and death can occur, particularly in patients presenting with a hepatocellular pattern of serum enzyme elevations (Case 4). Corticosteroids have been used but with uncertain effectiveness for the hepatic components of the hypersensitivity syndrome. Rechallenge with carbamazepine is associated with rapid and more severe recurrence and should be avoided. Cross reactivity with other aromatic anticonvulsants (phenytoin, phenobarbital, primidone, oxcarbazepine and lamotrigine) is common, but not invariable. Patients with severe hypersensitivity to carbamazepine should avoid exposure to other aromatic anticonvulsants and be switched instead to agents such as a benzodiazepine, valproate, levetiracetam, gabapentin or pregabalin.

Drug Class: Anticonvulsants

## CASE REPORTS

### Case 1. Immunoallergic hepatitis caused by carbamazepine.

[Modified from: Dertinger S, Dirschmid K, Vogel W, Drexel H. Immunosuppressive therapy for carbamazepine-induced hypersensitivity syndrome and hepatitis. J Hepatol 1998; 28: 356-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9514552)]

A 50 year old man with epilepsy was switched from valproate to carbamazepine and one month later presented with high fevers and fatigue. He was treated with amoxicillin and developed a diffuse maculopapular rash, adenopathy and jaundice within a few days. Laboratory testing showed eosinophilia (8%) and elevations in serum enzymes with mild jaundice (Table). Tests for viral hepatitis, autoimmune liver disease and liver imaging were negative or nonrevealing. Carbamazepine was continued for another 5 days when a liver biopsy showed evidence of drug induced liver disease. Because of worsening rash and hemorrhagic bullae, a single intravenous injection of prednisolone (250 mg) was given. He improved rapidly and was discharged after 12 days in the hospital, but returned a few days later with relapse in fever, rash and fatigue. Serum enzymes had risen as well. He was started on oral prednisone (~40 mg/day) and improved. The dose of prednisone was gradually decreased and was stopped 12 weeks later. In follow up, he was asymptomatic and had normal liver tests on chronic valproate therapy.

#### Key Points

Medication: | Carbamazepine (600 mg/day)
Pattern: | Mixed (R=4.6)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 4 weeks
Recovery: | Complete in 6 weeks
Other medications: | Amoxicillin after onset of fever (valproate in the past)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
4 weeks | 0 | 166 | 365 | 3.9 | 8% eosinophils
| 1 day | 334 | 311 | 5.2 | Given iv prednisolone once
Discharged after 12 days in hospital and readmitted 4 days later
6 weeks | 12 days | 324 | 452 | 2.2 | Worsening rash and fever
7 weeks | 2 weeks | 221 | 356 | 1.6 | Prednisone 1 mg/kg/day
2 months | 3 weeks | 85 | 240 | 1.3 | Prednisone tapered
3 months | 5 weeks | 15 | 82
4 months | 3 months | 14 | 64 | 0.3 | Prednisone stopped
6 months | 5 months | 15 | 76 | 0.3
Normal Values | | <42 | <115 | <1.2

#### Comment

A typical case of drug related rash with eosinophilia and systemic symptoms (DRESS), also referred to as anticonvulsant hypersensitivity syndrome or immunoallergic hepatitis due to carbamazepine. The presentation and course were typical with onset of fever, rash, lymphadenopathy, eosinophilia and a mixed-hepatocellular-cholestatic form of liver injury within 4 weeks of starting carbamazepine. The course of the liver disease was relatively mild and dominated by the systemic symptoms of fever and rash. While corticosteroids have not been proven to be beneficial in drug induced liver injury, this case demonstrates that they appear to rapidly ameliorate symptoms and signs of hypersensitivity, as evidenced in this patient by the rapid response in rash and fever to a single infusion of prednisone and the relapse in symptoms when corticosteroids were not continued. While corticosteroids may shorten the period of symptoms, they have not been shown to alter the ultimate outcome which is usually complete recovery. For this reason, corticosteroids should be used cautiously, limiting the dose and duration of therapy and, as in this case, documenting sustained recovery after withdrawal.

### Case 2. Cholestatic hepatitis caused by carbamazepine.

[Modified from: Larrey D, Hadengue A, Pessayre D, Choudat L, Degott C, Benhamou J-P. Carbamazepine-induced acute cholangitis. Dig Dis Sci 1987; 32: 554-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/3568943)]

A 79 year old woman with facial neuralgia was treated with carbamazepine and clobezepam and developed itching one month later. She continued the medications for another 3 weeks when she noted worsening fatigue and jaundice. She had no history of liver disease or alcohol abuse and was on no other medications except vincamine (a vasodilator and indole alkaloid). On examination she was jaundiced and had a low-grade fever, but had no features of chronic liver disease or hepatic failure. Laboratory testing showed eosinophilia (54%) and elevations in serum enzymes with mild jaundice (Table). Test for hepatitis A and B were negative; autoantibody testing revealed an ANA of 1:100. Ultrasonography showed no evidence of biliary obstruction. A liver biopsy demonstrated marked cholestasis, bile duct injury and mild lobular inflammation compatible with drug induced liver injury. There were no granulomas. All medications were stopped and she improved rapidly, liver tests returning to normal within 3 months. Clobazepam and vincamine were restarted and all tests remained normal.

#### Key Points

Medication: | Carbamazepine (200 mg/day)
Pattern: | Cholestatic (R=0.4)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 4 weeks to symptoms, 7 weeks to jaundice
Recovery: | Complete in 3 months
Other medications: | Clobazepam and vincamine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
7 weeks | 0 | 91 | 25 | 6.6 | 54% eosinophils
8 weeks | 1 week | 89 | 22 | 2.2 | Liver biopsy
9 weeks | 2 weeks | 48 | 11 | 1.1
13 weeks | 6 weeks | 52 | 4 | 0.8 | Clobazepam restarted
19 weeks | 12 weeks | 30 | 3
Normal Values | | <45 | <5 | <1.2

Some values estimated from Figure 3. Serum bilirubin levels converted from μmol to mg/dL.

#### Comment

This patient developed a cholestatic hepatitis with mild fever and marked eosinophilia but no rash and therefore not really drug related rash with eosinophilia and systemic symptoms (DRESS), although clearly liver injury with immunoallergic features. Recovery was rapid once carbamazepine was stopped, which had been delayed for 3 weeks despite symptoms of fatigue and itching. The roles of clobazepam (a benzodiazepine) and vincamine (a drug derived from vinca that is used to improve blood flow to the brain, but not available in the United States) were excluded by the absence of recurrence once they were restarted.

### Case 3. Vanishing bile duct syndrome caused by carbamazepine.

[Modified from: Forbes GM, Jeffrey GP, Shilkin KB, Reed WD. Carbamazepine hepatotoxicity: another cause of the vanishing bile duct syndrome. Gastroenterology 1992; 102: 1385-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/1551543)]

A 59 year old man developed fever, rash, abdominal pain and jaundice 2 months after starting carbamazepine for glossopharyngeal neuralgia. He had no history of liver disease, drank alcohol regularly but in moderation and had no risk factors for viral hepatitis. His other medical conditions included chronic obstructive airway disease and hypertension for which he had been taking nebulized salbutamol and oral captopril for more than a year. On initial examination he was febrile (39.7 ^o^C) and deeply jaundiced. He had a generalized erythematous, macular rash but with no mucosal involvement. There were no signs of chronic liver disease. Laboratory testing showed eosinophilia (20%) and elevations in serum enzymes with jaundice (Table). The INR was 2.06, but it corrected rapidly with vitamin K. Tests for autoantibodies were negative. Abdominal ultrasound and endoscopic retrograde cholangiography demonstrated no evidence of biliary obstruction. A liver biopsy demonstrated marked bile duct injury and portal inflammation. Carbamazepine was stopped and he was treated with oral prednisolone. The rash and fever improved rapidly and corticosteroids were tapered and stopped after 7 weeks. However, at the same time, jaundice deepened and he developed persistent pruritus. A repeat liver biopsy two months later showed lack of bile ducts and fibrotic septa extending from portal areas. Symptoms and jaundice gradually resolved over the next 10 months, but serum enzymes remained abnormal.

#### Key Points

Medication: | Carbamazepine (dose not given)
Pattern: | Cholestatic (R=0.4)
Severity: | 4+ (jaundice, hospitalization, abnormal INR)
Latency: | 2 months
Recovery: | Incomplete after 16 months
Other medications: | Captopril and salbutamol

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
2 months | 0 | 90 | 1030 | 12.4 | 20% eosinophils
4 months | 2 months | | | | Liver biopsy: ductopenia
12 months | 10 months | 56 | 420 | 1.6 | Liver biopsy: fibrosis
18 months | 16 months | 67 | 955 | 1.4 | Asymptomatic
Normal Values | | <42 | <135 | <1.2

Serum bilirubin levels converted from μmol/L to mg/dL.

#### Comment

This patient developed a drug rash, fever, eosinophilia and cholestatic hepatitis (DRESS) two months after starting carbamazepine. The cholestatic hepatitis was severe and prolonged and associated with vanishing bile ducts as shown by repeat liver biopsies. However, he eventually improved and the jaundice resolved. The ultimate prognosis, however, is uncertain. Vanishing bile ducts syndrome typically arises after an acute, severe cholestatic hepatitis with immunoallergic features.

### Case 4. Acute liver failure caused by carbamazepine.

[Modified from: Morales-Diaz M, Pinilla-Roa E, Ruiz I. Suspected carbamazepine-induced hepatotoxicity. Pharmacotherapy 1999; 19: 252-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/10030780)]

A 9 year old girl developed vomiting and diarrhea five months after starting carbamazepine (500 mg daily) for chronic seizure disorder. She was found to have marked elevations in serum enzymes but carbamazepine was continued as the diagnosis was thought to be acute viral hepatitis. Four days later she was admitted to the hospital because of worsening symptoms and jaundice. Serum bilirubin was 31 mg/dL, ALT 570 U/L, AST 550 U/L and alkaline phosphatase 1332 U/L and prothrombin index 35% of normal (Table). Over the next few days she remained deeply jaundice and developed lethargy and mild asterixis. Serum ammonia levels reached 138 μg/dL (normal <83). Tests for acute hepatitis A, B and C were negative and imaging of the liver showed no evidence of biliary obstruction. A liver biopsy showed changes suggestive of drug induced liver injury. Carbamazepine was stopped and corticosteroids were started. One week later she began to improve. Seizures were controlled with phenobarbital. She was discharged on tapering doses of corticosteroids. Two months after stopping carbamazepine, her liver tests were in the normal range and one year later she was without clinical or laboratory evidence of liver damage and was seizure free.

#### Key Points

Medication: | Carbamazepine (500 mg/day)
Pattern: | Hepatocellular (R=14.3)
Severity: | 4+ (hepatic failure)
Latency: | 5 months
Recovery: | 2 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
5 months | pre | 570 | 1332 | 31 | Emergency room
[+4 days] | pre | 385 | 385 | 22 | Admission, PT index 35%
[+8 days] | 4 days | 227 | 646 | 13
| 8 days | 130 | 687 | 9.5 | PT index = 21%
| 18 days | 72 | | 7.0
| 25 days | 91 | | 5.0 | PT index = 100%
7 months | 1 month | 72 | | 1.5
8 months | 2 months | 16 | 546 | 0.7
Normal Values | | <18 | <600 | <1.2

Serum bilirubin levels estimated from Figure 1. PT index, prothrombin index

#### Comment

This child developed an acute hepatitis 5 months after starting carbamazepine. Immunoallergic features were not present and the course was severe, marked by signs and symptoms of hepatic failure and deep jaundice. She ultimately recovered, however, improving rapidly once carbamazepine was stopped. Clearly, the most serious error that can be made in managing drug induced liver injury is to continue the medication in the face of significant injury.

## CASE REPORTS SUBMITTED TO LIVERTOX

Clinical cases of drug-induced liver injury that have been submitted to LiverTox ("Submit a Case Report" (https://livertox.niddk.nih.gov/)) are available for review. Most of these reference cases are from the Drug-Induced Liver Injury Network, but others are from users of LiverTox who have submitted data from an actual clinical case. All cases have been reviewed and cleared of personal identifiers and a brief comment added by the LiverTox editors. Click on the following link to view the submitted case reports that have been made publically available.

[underlined: Submitted Cases on Carbamazepine] (https://livertox.niddk.nih.gov/Home/ReferenceCases/allopurinol)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Carbamazepine – Tegretol®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Carbamazepine | 298-46-4 | C15-H12-N2-O | Carbamazepine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2017

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; mentions that carbamazepine has been linked to more than 250 cases of clinically apparent liver injury including 18 deaths).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury; liver injury due to carbamazepine can be a component of a generalized hypersensitivity reaction and result in a prominent and severe hepatitis which can be fatal).
McNamara JO. Pharmacology of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 583-608. (Textbook of pharmacology and therapeutics).
Brukker AB, Joustra UH. [Liver damage caused by carbamazepine] Ned Tijdschr Geneeskd 1966; 110: 1181-3. Dutch. (30 year old man with difficult to control epilepsy on trimethadione, phenobarbital, ethosuximide and carbamazepine for 3 months developed vomiting and abnormal liver tests [bilirubin 1.9 mg/dL, ALT 85 U/L, Alk P 1.5 times ULN, no eosinophilia], which continued to worsen despite stopping trimethadione and ethosuximide; mild improvement on stopping carbamazepine; restarting led rapidly to abdominal pain and worsening jaundice [bilirubin 3.3 mg/dL, ALT 450 U/L, Alk P 2 times ULN], resolving within a month of stopping). 5947216
Ramsay ID. Carbamazepine-induced jaundice. Br Med J 1967; 4: 155. (65 year old man developed dark urine without fever or rash 3 weeks after starting carbamazepine [bilirubin 5.8 mg/dL, ALT 120 U/L, Alk P 4 times ULN, no eosinophilia], improving on stopping and recurring within 4 days of rechallenge [bilirubin 2.2 mg/dL, ALT 210 U/L, Alk P 4 times ULN], recovery requiring 4 months). 6053983
Fellows WR. A case of aplastic anemia and pancytopenia with tegretol therapy. Headache 1969; 9: 92-5. (59 year old man developed aplastic anemia and incarcerated hernia 6 weeks after restarting carbamazepine, became jaundiced and had a complicated course resulting in death; autopsy showed “toxic hepatitis”, but difficult to attribute course to carbamazepine hepatotoxicity vs ischemic injury and jaundice of sepsis). 5804525
Zucker P, Daum F, Cohen MI. Fatal carbamazepine hepatitis. J Pediatr 1977; 91: 667-8. (14 year old girl developed fatigue and jaundice without fever or rash 6 months after starting carbamazepine and phenobarbital [bilirubin 10.8 mg/dL, ALT 1360 U/L, Alk P 2 times ULN], progressing to liver failure and death after 43 days despite stopping both drugs). 908993
Huf RL, Schain RJ. Liver functions in children receiving carbamazepine. J Pediatr 1978; 93: 884. (Letter in response to Zucker et al [1977]; testing 19 children on carbamazepine for 6 months-5 years found none with elevations in ALT, AST or Alk P). 712504
Knudsen L, Jensen KB. [Drug-induced hepatitis. Review and report of a case caused by carbamazepine (Tegretol)] Ugeskr Laeger 1979; 141: 3160-3. Danish. 524492
Levander HG. Granulomatous hepatitis in a patient receiving carbamazepine. Acta Med Scand 1980; 208: 333-5. (60 year old woman developed fever, right upper quadrant pain and fatigue 3 weeks after starting carbamazepine [bilirubin 1.0 mg/dL, ALT 270 U/L, Alk P 2 times ULN, eosinophils 650/µ L]; liver biopsy showed granulomatous inflammation; positive rechallenge documented by repeat liver biopsy, resolving within a month of stopping). 7446211
Mitchell MC, Boitnott JK, Arregui A, Maddrey WC. Granulomatous hepatitis associated with carbamazepine therapy. Am J Med 1981; 71: 733-5. (Two men, ages 52 and 54 years, developed dark urine 3 weeks after starting carbamazepine, both with fever but no rash or eosinophilia [bilirubin 1.5 and 3.4 mg/dL, ALT 61 and 145 U/L, Alk P 80 and 236 U/L], biopsies showed granulomatous inflammation; both recovered within 4 weeks). 7282758
Levy M, Goodman MW, Van Dyne BJ, Sumner HW. Granulomatous hepatitis secondary to carbamazepine. Ann Intern Med 1981; 95: 64-5. (Three patients who developed fever, fatigue and abdominal pain 3-4 weeks after starting carbamazepine [bilirubin normal to 3.2 mg/dL, AST 20, 95 and 38 U/L, Alk P 1.5-2 times ULN, no eosinophilia]; biopsies showed granulomas; rechallenge in one led to immediate appearance of fever and rash; rapid recovery). 7247130
Hopen G, Nesthus I, Laerum OD. Fatal carbamazepine-associated hepatitis. Report of two cases. Acta Med Scand 1981; 210: 333-5. (Two women, ages 23 and 37 years, developed rash and fever followed by jaundice 8 days after starting carbamazepine [peak bilirubin 7.9 and 14.0 mg/dL GGT 5350 and 205 U/L, ALT unknown and 1325 U/L], both had progressive liver failure and died; autopsies showed massive necrosis). 7315533
Ponte CD. Carbamazepine-induced thrombocytopenia, rash, and hepatic dysfunction. Drug Intell Clin Pharm 1983; 17: 642-4. (33 year old woman developed fever and rash without eosinophilia 3 weeks after starting carbamazepine [bilirubin not given, AST 127 U/L, Alk P 304 U/L, platelets 55,000/µL ], began to improve when switched to phenobarbital, but full recovery not documented). 6225634
Soffer EE, Taylor RJ, Bertram PD, Haggitt RC, Levinson MJ. Carbamazepine-induced liver injury. South Med J 1983; 76: 681-3. (2 women, ages 28 and 22 years, developed jaundice 2 and 5 weeks after starting carbamazepine, one with fever, neither had rash [bilirubin 3.2 and 7.3 mg/dL, AST 1130 and 174 U/L, Alk P 211 and 870 U/L, 4% and 13% eosinophilia], resolving within 6 and 3 weeks of stopping). 6844981
Keränen T, Sivenius J. Side effects of carbamazepine, valproate and clonazepam during long-term treatment of epilepsy. Acta Neurol Scand Suppl 1983; 97: 69-80. (Review of side effects mentioning that carbamazepine and valproate have rare hepatic side effects, but clonazepam does not). 6424398
Yeung Laiwah AC, Rapeport WG, Thompson GG, MacPhee GJA, Philip MF, Moore MR, Brodie MJ, et al. Carbamazepine-induced non-hereditary acute porphyria. Lancet 1983; 1: 790-2. (Two patients on high doses of carbamazepine had decreased uroporhpyrinogen I synthase [URO-S] and elevated delta aminolevulinic acid levels and 1 developed symptoms of acute intermittent porphyria; cohort of patients on carbamazepine had slightly reduced levels of URO-S). 6132132
Perucca E, Hedges A, Makki KA, Ruprah M, Wilson JF, Richens A. A comparative study on the relative enzyme inducing properties of anticonvulsant drugs in epileptic patients. Br J Clin Pharmac 1984; 18: 401-10. (Cross sectional study of antipyrine clearance in 122 patients with epilepsy, found dose dependent increase in clearance in those on phenytoin, phenobarbital and carbamazepine, but not on valproate). 6435654
Rigau Cañardo J, Bruguera M, Sese J, Morlans G. [Acute cholestatic hepatitis due to carbamazepine]. Gastroenterol Clin Biol 1984; 8: 769-70. French. (54 year old woman developed fatigue 1 month after starting carbamazepine [bilirubin 2.4 mg/dL, A110 90 U/L, Alk P 242 U/L], resolving within 1 month of stopping and recurrence of rash and fatigue after reexposure to a single dose 6 months later). 6526232
Diaz-Torres MA, Caraballo R, Ollero M, Lissen E. [Hepatitis caused by carbamazepine] Med Clin (Barc) 1984; 83: 823. Spanish. (64 year old woman developed rash and fever 1 week after starting carbamazepine, followed by dark urine, lymphadenopathy, and pleuritic pain [bilirubin 1.9 mg/dL, ALT 205 U/L, Alk P 1622 U/L, 14% eosinophilia], resolving within 3 weeks of stopping). 6527581
Bastús JB. [Hepatitis caused by carbamazepine] Med Clin (Barc) 1985; 84: 543. Spanish. (Patient developed fever and anorexia 1 month after starting carbamazepine [bilirubin 2.3 mg/dL, ALT 90 U/L, GGT 696 U/L], biopsy showed cholestatic hepatitis without granulomas; rapid recovery on stopping). 3999827
Okada Y, Watanabe T, Kajiwara E, Tsuji H, Murai K, Akagi K, Onoyama K, Omae T. [Two cases of carbamazepine induced hepatitis] Nippon Naika Gakkai Zasshi 1984; 73: 1189-94. Japanese. 6512351
Paladini G, Marinig L. [Immuno-allergic side effects induced by the administration of carbamazepine. Case contribution] Minerva Med 1984; 75: 1651-5. Italian. 6462508
Davion T, Capron JP, Andrejak M, Geoffroy P, Capron-Chivrac D, Quénum C. [Acute hepatitis due to carbamazepine (Tegretol). Study of a case and review of the literature]. Gastroenterol Clin Biol 1984; 8: 52-6. French. (28 year old woman developed fever, rash and eosinophilia 2 months after starting carbamazepine [bilirubin 3.8 mg/dL, ALT 250 U/L, Alk P 1080 U/L]; rechallenge led to fever and jaundice within 2 days). 6698343
Moore NC, Lerer B, Meyendorff E, Gershon S. Three cases of carbamazepine toxicity. Am J Psychiatry 1985; 142: 974-5. (44 year old woman developed nausea, fever and jaundice 4 weeks after starting carbamazepine [bilirubin 5.7 mg/dL, ALT 384 U/L, Alk P 623 U/L], resolving in 6 weeks; 2 other cases of rash and one of “aplastic anemia” [no hemoglobin levels given]). 3161347
Canterbury RJ. The side effects of carbamazepine. Am J Psychiatry 1986; 143: 395. (Letter in response to Moore et al [1985] without new information). 3953883
Davion T, Capron-Chivrac D, Andrejak M, Capron JP. [Hepatitis due to antiepileptic agents] Gastroenterol Clin Biol 1985; 9: 117-26. French. (Review of 15 cases of carbamazepine hepatotoxicity in the literature; onset in 3-4 weeks in most cases, but occasionally longer; granulomatous hepatitis in 8 of 14 cases with biopsy, these granulomatous cases being benign; three reports of acute liver failure). 3920108
Galeone D, Lamontanara G, Torelli D. Acute hepatitis in a patient treated with carbamazepine. J Neurol 1985; 232: 301-3. (Child switched from phenobarbital to carbamazepine developed worsening seizures and coma [normal bilirubin, ALT 2138 U/L, GGT 92 U/L, renal failure], resolving rapidly on dialysis: injury may have been due to ischemia rather than carbamazepine injury). 4056837
Costa JF, Sramek JJ, Herrera JM. Hepatic reaction to carbamazepine. J Clin Psychopharmacol 1986; 6: 251-2. (26 year old man developed malaise and vomiting 6 weeks after starting carbamazepine [bilirubin not mentioned, ALT 75 U/L, Alk P 75 U/L], resolving rapidly upon stopping). 3734150
Luke DR, Rocci ML Jr, Schaible DH, Gerguson RK. Acute hepatotoxicity after excessively high doses of carbamazepine on two occasions. Pharmacother 1986; 6: 108-11. (2 year old girl on carbamazepine and phenytoin developed coma and hypotension and marked ALT elevations [5220 and 4020 U/L] with minimal bilirubin elevations [1.6 and 1.4 mg/dL] on two occasions when carbamazepine levels were high; also associated with hypotension and stupor so that ischemic damage may also have played a role). 3737441
Swinburn BA, Croxson MS, Miller MV, Crawford KB. Carbamazepine induced granulomatous hepatitis. N Z Med J 1986; 99: 167. (59 year old man developed fever and jaundice 3 weeks after starting carbamazepine [bilirubin 4.5 mg/dL, AST 117 U/L, Alk P 376 U/L], liver biopsy showed granulomas; improvement with dose reduction and resolution with stopping and switching to phenytoin). 3457299
Larrey D, Hadengue A, Pessayre D, Choudat L, Degott C, Benhamou J-P. Carbamazepine-induced acute cholangitis. Dig Dis Sci 1987; 32: 554-7. (79 year old woman developed itching 4 weeks and fever and jaundice [no rash] 7 weeks after starting clonazepam and carbamazepine [bilirubin 6.6 mg/dL, ALT 91 U/L, Alk P 5 times ULN, 54% eosinophils]; liver biopsy showed cholestasis and “cholangitis”, resolving within 3 months of stopping carbamazepine, clonazepam being restarted: Case 2). 3568943
Reinikainen KJ, Keranen T, Halonen T, Komulainen H, Riekkinen PJ. Comparison of oxcarbazepine and carbamazepine: a double-blind study. Epilepsy Research 1987; 1: 284-9. (Among 18 patients on carbamazepine and 16 on oxcarbazepine, 2 developed transient ALT and AST elevations neither requiring dose adjustment). 3504404
Noguerado A, Isasia T, Martínez MC, García-Sánchez A. [Granulomatous hepatitis caused by carbamazepine] Rev Clin Esp 1987; 181:116. Spanish. (53 year old woman developed fever, rash and anorexia 4 weeks after starting carbamazepine with eosinophilia and elevated Alk P [1002 U/L], liver biopsy showed granulomas, eosinophils, and spotty necrosis and inflammation; repeat biopsy 3 months later was normal). 3628894
Pellock JM. Carbamazepine side effects in children and adults. Epilepsia 1987; 28 Suppl 3: S64-70. (Analysis of side effects among 220 children on carbamazepine; skin rash in 5% and elevated liver tests in 6% but none “were of clinical significance.” Reports to Ciba-Geigy from 1975-86 included 45 cases of hepatitis and estimate that 5% to 10% of patients had serum enzyme elevations). 2961558
Shear NH, Spielberg SP. Anticonvulsant hypersensitivity syndrome: in vitro assessment of risk. J Clin Invest 1988; 82: 1826-32. (PBMC cytotoxicity in response to drug metabolites was common among 53 patients with hypersensitivity to anticonvulsants including 35/36 to phenytoin, 22/27 to phenobarbital and 25/27 to carbamazepine; 51% had hepatitis). 3198757
Robbie MJ, Scurry JP, Stevenson P. Carbamazepine-induced severe systemic hypersensitivity reaction with eosinophilia. Drug Intell Clin Pharm 1988; 22: 783-4. (35 year old woman developed rash 3 weeks after starting carbamazepine, followed by fever and dyspnea with eosinophilia, respiratory and renal failure, responding to prednisone but then relapsing, developing jaundice late [bilirubin 8.8 mg/dL, AST 120 U/L, Alk P 2220 U/L], death from multiorgan failure 12 weeks later). 3229345
Matsukura H, Suzuki Y. A case of hepatitis associated with carbamazepine therapy. Eur J Pediatr 1988; 147: 666. (9 year old girl developed fever and rash 4 weeks after starting carbamazepine [bilirubin normal, ALT 385 U/L, Alk P 4x ULN], worsening transiently with jaundice, but resolving within 2 weeks of stopping). 3181214
Horowitz S, Patwardhan R, Marcus E. Hepatotoxic reactions associated with carbamazepine therapy. Epilepsia 1988; 29: 149-54. (2 women, ages 71 and 75 years, developed fatigue and jaundice 2 and 4 weeks after starting carbamazepine [bilirubin 11.4 mg/dL and normal, AST 134 and ALT 1430 U /L, Alk P 356 and 970 U/L], resolving within 4 and 6 months of stopping; no eosinophilia, fever or rash: literature review). 3280305
Sillanpää M, Pihlaja T. Oxcarbazepine (GP 47 680) in the treatment of intractable seizures. Acta Paediatr Hung 1988-1989; 29: 359-64. 3269269
Aldenhövel HG. The influence of long-term anticonvulsant therapy with diphenylhydantoin and carbamazepine on serum gamma-glutamyltransferase, aspartate aminotransferase, alanine aminotransferase and alkaline phosphatase. Eur Arch Psychiatry Neurol Sci 1988; 237: 312-6. (Among 54 patients on phenytoin and 56 on carbamazepine: elevations in GGT [14-283 U/L] were present in 91% and 64%, ALT [5-81 U/L] in 28% and 9%, and Alk P [71-216 U/L] in 39% vs 14%, most elevations were modest; GGT elevations were dose related, but not the others). 2901959
Rodríguez Hernández H, Dehesa Violante M, Vega Ramos B, Méndez Gutiérrez TH. [Granulomatous hepatitis secondary to ingestion of carbamazepine. Report of a case] Rev Gastroenterol Mex 1989; 54: 239-41. Spanish. 2694294
Durelli L, Massazza U, Cavallo R. Carbamazepine toxicity and poisoning. Incidence, clinical features and management. Med Toxicol Adverse Drug Exp 1989; 4: 95-107. (Review of pharmacology and toxicity of carbamazepine; symptoms of overdose are largely neurological). 2654545
Gillis S, Dann EJ. [Carbamazepine-associated hepatitis] Harefuah 1990; 119: 430-1. Hebrew. 2074067
Askmark H, Wiholm B. Epidemiology of adverse reactions to carbamazepine as seen in a spontaneous reporting system. Acta Neurol Scand 1990; 81: 131-40. (Analysis of 505 reports of adverse reaction to carbamazepine during 92 million dose-days from 1965-1987 in Sweden; 71 were liver related [16/100,000 treatment years], 21 with isolated ALT elevation after 4-46 days, 18 with ALT and Alk P elevations after 16-60 days, and 25 with jaundice after 6 days to 2 years). 2327233
Frey B, Schubiger G, Musy JP. Transient cholestatic hepatitis in a neonate associated with carbamazepine exposure during pregnancy and breast-feeding. Eur J Pediatr 1990; 150: 136-8. (Persistent jaundice at 3 weeks in male infant being breastfed by mother on carbamazepine [direct/total bilirubin 2.4/13.0 mg/dL, ALT 31 U/L, Alk P 402 U/L], liver biopsy showed cholestatic hepatitis, with rapid recovery on stopping). 2279511
Rivey MP, Stone JD. Carbamazepine hypersensitivity reaction. Brain Inj 1991; 5: 57-62. (30 year old man developed fatigue and itching 3 weeks after starting carbamazepine [bilirubin 2.7 mg/dL, ALT 228 U/L, Alk P 1466 U/L, 23% eosinophils and atypical lymphocytosis], with rash and Stevens-Johnson syndrome requiring corticosteroids, resolving within 6 weeks). 1828383
Kleier RS, Breneman DL, Boiko S. Generalized pustulation as a manifestation of the anticonvulsant hypersensitivity syndrome. Arch Dermatol 1991; 127: 1361-4. (2 men, ages 21 and 49 years, developed rash after 3-4 weeks of phenytoin evolving into sterile pustules; eosinophilia and fever [bilirubin normal, ALT 57 and 660 U/L, Alk P 85 and 117 U/L], worsening on switching to carbamazepine and phenobarbital, resolving after switching to clonazepam). 1832535
Wyllie E, Wyllie R. Routine laboratory monitoring for serious adverse effects of antiepileptic medications: the controversy. Epilepsia 1991; 32 (Suppl 5): S74-9. (The effectiveness of monitoring serum enzyme levels in patients starting anticonvulsant therapy in preventing acute liver failure is controversial and of unproven benefit). 1743173
Merlob P, Mor N, Litwin A. Transient hepatic dysfunction in an infant of an epileptic mother treated with carbamazepine during pregnancy and breastfeeding. Ann Pharmacother 1992; 26: 1563-5. (Newborn girl being breast fed by a mother taking carbamazepine had persisting jaundice in first 2 weeks of life [direct/total bilirubin 1.4/3.4 mg/dL, ALT 32 U/L, Alk P 293 U/L on day 5], resolving rapidly with stopping breastfeeding). 1362364
Forbes GM, Jeffrey GP, Shilkin KB, Reed WD. Carbamazepine hepatotoxicity: another cause of the vanishing bile duct syndrome. Gastroenterology 1992; 102: 1385-8. (59 year old man developed fever, rash and jaundice 2 months after starting carbamazepine [bilirubin 12.4 mg/dL, AST 99 U/L, Alk P 1030 U/L], evolving into chronic cholestasis and vanishing bile duct syndrome, which improved clinically, but liver tests were still abnormal 1 year later: Case 3). 1551543
Pirmohamed M, Kitteringham NR, Breckenridge AM, Park BK. Detection of an autoantibody directed against human liver microsomal protein in a patient with carbamazepine hypersensitivity. Br J Clin Pharmacol 1992; 33: 183-6. (16 year old boy developed fever, rash, and jaundice 6 weeks after starting carbamazepine [bilirubin 2.6 mg/dL, ALT 328 U/L, Alk P 617 U/L, 39% eosinophils], resolving within 6 weeks of stopping, cytotoxicity assays positive to drug treated microsomes and autoantibody to an unknown microsomal protein found). 1550698
Mondragon R, Mieli-Vergani G, Heaton ND, Mowat AP, Vougas V, Williams R, Tam KC. Liver transplantation for fulminant liver failure in children. Transpl Int 1992; 5 (Suppl 1): S206-8. (Among 7 children undergoing emergency liver transplantation for acute liver failure between 1988 and 1991, 2 were attributed to carbamazepine hepatotoxicity). 14621778
Friis ML, Kristensen O, Boas J, Dalby M, Deth SH, Gram L, Mikkelsen M, et al. Therapeutic experiences with 947 epileptic out-patients in oxcarbazepine treatment. Acta Neurol Scand 1993; 87: 224-7. (Retrospective study of 947 patients treated with oxcarbazepine in 8 centers from 1981-90: adverse events in 33%, rash in 6%, elevations in laboratory results [ALT, AST, GGT or WBC] in <2%). 8475694
Handfield-Jones SE, Jenkins RE, Whittaker SJ, Besse CP, McGibbon DH. The anticonvulsant hypersensitivity syndrome. Br J Dermatol 1993; 129: 175-7. (3 patients developed fever and rash 3, 4 and 10 weeks after starting phenytoin or carbamazepine; two required corticosteroids; only 1 had hepatitis; 1 died of multiorgan failure, others switched to valproate or clobazam without recurrence). 7654579
Froomes PR, Stewart MR. A reversible parkinsonian syndrome and hepatotoxicity following addition of carbamazepine to sodium valproate. Aust N Z J Med 1994; 24: 413-4. (67 year old woman developed ataxia 1 month after starting carbamazepine followed by lethargy and jaundice [bilirubin 2.5 mg/dL, AST 164 U/L, Alk P 455 U/L], resolving rapidly on stopping and recurring rapidly on rechallenge). 7980246
Gall H, Merk H, Scherb W, Sterry W. [Anticonvulsant hypersensitivity syndrome to carbamazepine] Hautarzt 1994; 45: 494-8. German. 7928347
Baischer W, Wagner A, Seidler D, Musalek M, Laggner A. [Carbamazepine poisoning: protracted course with development of intestinal atony and hepatic toxicity] Wien Klin Wochenschr 1994; 106: 27-9. German. 8135028
Green VJ, Pirmohamed M, Kitteringham NR, Gaedisk A, Grant DM, Boxer M, Burchell B, Park BK. Genetic analysis of microsomal epoxide hydrolase in patients with carbamazepine hypersensitivity. Biochem Pharmacol 1995; 50:1353-9. (Analysis of the microsomal epoxide hydrolase gene in 10 patients with carbamazepine hypersensitivity syndrome found many mutations, but no consistent single mutation). 7503783
Mauri-Hellweg D, Bettens F, Mauri D, Brander C, Hunziker T, Pichler WJ. Activation of drug-specific CD4+ and CD8+ T cells in individuals allergic to sulfonamides, phenytoin, and carbamazepine. J Immunol 1995; 155: 462-72. (In vitro lymphocyte studies on 20 patients with drug allergy, found proliferation in response to specific drug, including carbamazepine, with proliferation of both CD4 and CD8 T cells and increase in CD-25 and HLA-DR expression and production of IL5 and IFNγ). 7602118
Kong KH. Carbamazepine-induced hepatitis in a patient with cervical myelopathy. Arch Phys Med Rehabil 1996; 77: 305-6. (66 year old man developed fever and jaundice 5 weeks after starting carbamazepine [bilirubin 8.8 mg/dL, ALT 155 U/L, Alk P 413 U/L, 27% eosinophils], resolving within a month of stopping). 8600877
Hintsche-Kilger BB, Fengler JD, Baumgarten R. [Mononucleosis syndrome with hypersensitivity hepatitis following carbamazepine administration] Z Arztl fortbild(Jena) 1990; 85: 551-3. 2144387
Martínez P, González de Etxabarri S, Ereño C, López G, Hinojal C, Teira R. [Acute severe hepatic insufficiency caused by carbamazepine]. Rev Esp Enferm Dig 1993; 84: 124-6. Spanish. (61 year old man developed acute hepatitis 2 weeks after starting carbamazepine [bilirubin 3.6 mg/dL, ALT 7610 U/L, Alk P 580 U/L] with encephalopathy and prolongation of protime, resolving 2 months after stopping). 8398372
Wallace SJ. A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf 1996; 15: 378-93. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine and none on tiagabine or gabapentin). 8968693
Dertinger S, Dirschmid K, Vogel W, Drexel H. Immunosuppressive therapy for carbamazepine-induced hypersensitivity syndrome and hepatitis. J Hepatol 1998; 28: 356-7. (50 year old man developed fever, headaches, rash, and lymphadenopathy followed by jaundice 1 month after starting carbamazepine [bilirubin 3.9 mg/dL, ALT 166, Alk P 365 U/L], responding to single dose of prednisone and then transiently relapsing: Case 1). 9514552
Nathan DL, Belsito DV. Carbamazepine-induced pseudolymphoma with CD-30 positive cells. J Am Acad Dermatol 1998; 38: 806-9. (44 year old woman with a history of phenytoin sensitivity developed fever, lymphadenopathy, pneumonitis, and rash one month after starting carbamazepine [bilirubin not given, AST 282 U/L, Alk P 44 U/L] and atypical CD-30+ T cells in blood, resolution in 3 weeks on stopping). 9591791
Schlienger RG, Shear NH. Antiepileptic drug hypersensitivity syndrome. Epilepsia 1998; 39 (Suppl 7): S3-7. (Review of clinical features of anticonvulsant hypersensitivity syndrome). 9798755
Kaufman KR. Carbamazepine, hepatotoxicity, organic solvents, and paints. Seizure 1999; 8: 250-2. (48 year old man with mania developed transient ALT elevations [peak 234 U/L, elevated for one month] without allergic features ~4 months after starting carbamazepine, with normal values for 8 years thereafter: adaptation vs incidental toxicity of concurrent organic solvent exposure). 10452926
Hamer HM, Morris HH. Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Clevel Clin J Med 1999; 66: 239-45. (Anticonvulsant hypersensitivity syndrome occurs in 1-5/10,000 users, higher risk in African Americans and affected siblings; liver involvement common, but most cases anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis). 10199060
Morales-Diaz M, Pinilla-Roa E, Ruiz I. Suspected carbamazepine-induced hepatotoxicity. Pharmacotherapy 1999; 19: 252-5. (9 year old girl developed hepatitis 5 months after starting carbamazepine evolving to acute liver failure [bilirubin ~12 mg/dL, ALT 570 U/L, Alk P 1332 U/L, protime 35%], ultimately resolving after 2-3 months despite delay in stopping drug: Case 4). 10030780
Petter G, Haustein UF. [Stevens-Johnson syndrome with transition to toxic epidermal necrolysis after carbamazepine administration, heroin and alcohol abuse] Hautarzt 1999; 50: 884-8. German. 10663024
Knowles SR, Shapiro LE, Shear NH. Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf 1999; 21: 489–501. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant, liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to acute liver failure. High mortality rate with jaundice; other organs include muscle, kidney, brain, heart and lung. Pseudolymphoma syndrome and serum sickness like syndrome are separate complications of anticonvulsants. Role of corticosteroids uncertain; cross reactivity among the agents should be assumed). 10612272
Nari G. [Carbamazepine-induced hepatitis. A case report] Acta Gastroenterol Latinoam 1999; 29: 277-8. Spanish. 10599404
Hamer HM, Morris HH. Successful treatment with gabapentin in the presence of hypersensitivity syndrome to phenytoin and carbamazepine: a report of three cases. Seizure 1999; 8: 190-2. (3 patients developed rash, fever, lymphadenopathy and eosinophilia 4-6 weeks after starting either phenytoin or carbamazepine [bilirubin 0.5-1.8 mg/dL, ALT 866-1402 U/L, Alk P 69-364 U/L], resolving after stopping and not recurring during gabapentin therapy). 10356381
Haukeland JW, Jahnsen J, Raknerud N. [Carbamazepine-induced hepatitis] Tidsskr Nor Laegeforen 2000; 120: 2875-7. Norwegian. 11143408
Descamps V, Valance A, Edlinger C, Fillet A-M, Grossin M, Lebrun-Vignes B, Belaich S, Crickx B. Association of human herpesvirus 6 infection with drug reaction with eosinophilia and systemic symptoms. Arch Dermatol 2001; 137: 301-4. (Among 7 patients with DRESS syndrome, all had antibody to HHV-6, 2 in rising titers, 4 with IgM, none had HHV-6 DNA: 5 cases were due to carbamazepine, 1 sulfasalazine and 1 ibuprofen). 11255328
Sullivan JR, Shear NH. The drug hypersensitivity syndrome. What is the pathogenesis? Arch Dermatol 2001; 137: 357-64. (Review of clinical features, major causes and suspected pathogenesis of DRESS: major causes are aromatic anticonvulsants, abacavir, azathioprine, and sulfonamides). 11255340
Grieco A, Alfei B, Di Rocco P, Miele L, Biolcati G, Griso D, Vecchio FM, et al. Non-alcoholic steatohepatitis induced by carbamazepine and variegate porphyria. Eur J Gastroenterol Hepatol 2001; 13: 973-5. (42 year old woman developed diffuse bullous lesions 3 months after starting carbamazepine with elevated porphyrins and proteinuria [bilirubin normal, ALT 92 U/L, Alk P 406 U/L], liver biopsy showed fat, cholestasis and mild inflammation). 11507366
Queyrel V, Catteau B, Michon-Pasturel U, et al. [DRESS syndrome after sulfasalazine and carmazepine: report of two cases]. Rev Med Interne 2001; 22: 582-6. French. (21 year old man developed rash, fever and lymphadenopathy 3 weeks after starting carbamazepine [bilirubin not mentioned, ALT 7 times ULN, Alk P 311 U/L, eosinophils 500/μL], responding clinically to prednisone, full recovery in 2 months). 11433569
Yamaki M, Yoshida I. [A case of acute renal failure and liver dysfunction induced by carbamazepine (CBZ)] Nippon Jinzo Gakkai Shi 2001; 43: 357-61. Japanese. 11431905
Nashed MH, Liao L. Possible atypical cross-sensitivity between phenytoin and carbamazepine in the anticonvulsant hypersensitivity syndrome. Pharmacother 2001; 21: 502-5. (73 year old woman developed rash, fever and confusion 3-4 weeks after starting phenytoin and failed to improve when switched to carbamazepine [peak bilirubin 0.7 mg/dL, ALT 77 U/L, Alk P 521 U/L, 19% eosinophils], resolving rapidly upon stopping both). 11310525
Garcia M, Mhanna MJ, Chung-Park MJ, Davis PH, Srivastava MD. Efficacy of early immunosuppressive therapy in a child with carbamazepine-associated vanishing bile duct and Stevens-Johnson syndromes. Dig Dis Sci 2002; 47: 177-82. (4 year old developed necrotizing rash and fever 4 months after starting carbamazepine [bilirubin 4.0 mg/dL, ALT 673 U/L, Alk P 481 U/L, GGT 613 U/L], Stevens-Johnson syndrome; biopsy showing “early” vanishing bile duct syndrome, treated with corticosteroids with rapid response, but slow decline in GGT and cholesterol at the time of 6 week follow up). 11837721
Kalapos M. Carbamazepine-provoked hepatotoxicity and possible aetiopathological role of glutathione in the events: retrospective review of old data and call for new investigation. Adverse Drug React Toxicol Rev 2002; 21: 123-41. (Extensive review of metabolism of carbamazepine: it is partially metabolized to epoxide by CYP 3A4 which then may be conjugated to glutathione; phenolic metabolites of uncertain source; analysis of case reports of hepatotoxicity indicates high fatality rate in children, and fatal cases often lacked signs of hypersensitivity and received multiple anticonvulsants). 12298421
Ramos AMO, Gayotto LCC, Clemente CM, Mello EA, Luz KG, Freitas ML. Reversible vanishing bile duct syndrome induced by carbamazepine. Eur J Gastroenterol Hepatol 2002; 14: 1019-22. (26 year old man on carbamazepine for 4 years was found to have an elevated GGT [384 U/L] with normal bilirubin, ALT, and Alk P; GGT remained high and liver biopsy showed ductopenia with minimal inflammation; withdrawal of carbamazepine was followed by minimal improvement). 12352223
Frey B, Braegger CP, Ghelfi D. Neonatal cholestatic hepatitis from carbamazepine exposure during pregnancy and breast feeding. Ann Pharmacother 2002; 36: 644-7. (Newborn boy developed jaundice and mild elevations in GGT, Alk P and ALT 3 to 4 weeks after difficult birth to mother on carbamazepine who breastfed; two previous cases discussed). 11918515
Bin-Nakhi HA, Sadeq S, Pinto RG, Habeeb Y. Anticonvulsant hypersensitivity syndrome: report of 2 cases from Kuwait. Med Princ Pract 2003; 12: 197-9. (7 year old girl developed rash and fever 1 month after starting carbamazepine with lymphadenopathy, facial edema, strawberry tongue followed by jaundice [bilirubin 5.2 mg/dL, ALT 230, Alk P 369 U/L], resolving within 7 weeks of swtiching to valproate). 12766341
Choi TS, Doh KS, Kim SH, Jang MS, Suh KS, Kim ST. Clinicopathological and genotypic aspects of anticonvulsant-induced pseudolymphoma syndrome. Brit J Dermatol 2003; 148: 730-6. (8 cases of pseudolymphoma syndrome from Korea with maculopapular rash, fever, lymphadenopathy and facial edema arising 3-24 [mean=7] weeks after starting anticonvulsant, elevated liver tests in 5). 12752131
Penela Vélez de Guevara MT, Puente Sánchez MC, Jiménez Moya AI, Herrera Martín M, Romero Escós MD. [Erythroderma and hepatitis]. An Pediatr (Barc) 2004; 61: 353-4. Spanish. (11 year old girl developed high fever, sore throat and rash followed by adenopathy, desquamation and severe hepatitis 40 days after starting oxcarbazepine [peak bilirubin 20.6 mg/dL, ALT 25 times ULN], ultimately resolving completely). 15456599
Parikh S, Dillon LC, Scharf SL. Hepatotoxicity possibly due to paracetamol with carbamazepine. Intern Med J 2004; 34: 441-2. (80 year old woman developed liver injury while in hospital on multiple medications including carbamazepine and 4 g of acetaminophen daily [bilirubin 0.7 mg/dL, ALT 974 U/L, Alk P 161 U/L, INR 1.4], given NAC and gradually improved). 15271182
Chung WH, Hung SI, Hong HS, Hsih MS, Yang LC, Ho HC, Wu JY, et al. Medical genetics: a marker for Stevens-Johnson syndrome. Nature 2004; 428 (6982): 486. (Initial description of association of HLA-B*1502 with SJS due to carbamazepine, the allele being present in 100% of subjects with SJS vs 3% of carbamazepine tolerant and 8.6% of the normal [Chinese] population). 15057820
Durán-Ferreras E, Mir-Mercader J, Morales-Martínez MD, Martínez-Parra C. [Anticonvulsant hypersensitivity syndrome with severe repercussions in the skin and kidneys due to carbamazepine] Rev Neurol 2004; 38: 1136-8. Spanish. (26 year old woman developed rash, fever and facial edema, 4 weeks after starting carbamazepine with eosinophilia [7%], ALT elevations, and renal insufficiency requiring dialysis; later had fever, rash and ALT elevations in response to phenytoin). 15229826
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 10 were attributed to phenytoin, 10 to valproate and 1 to carbamazepine, but none to other anticonvulsants). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs, of which 1 was attributed to phenytoin, 1 to valproate and 1 to carbamazepine, but none to other anticonvulsants). 16165719
Wadhawan M, Tyagi P, Malhotra V, Sakhuja P, Puri AS. Reversible cholestatic hepatitis due to carbamazepine in an adolescent. Indian J Gastroenterol 2005; 24: 172-3. (13 year old boy developed rash and fever 10 weeks after starting carbamazepine, [bilirubin 14 mg/dL, ALT 156 U/L, Alk P 1414 U/L], resolving within 12 weeks of stopping). 16204911
Syn WK, Naisbitt DJ, Holt AP, Pirmohamed M, Mutimer DJ. Carbamazepine-induced acute liver failure as part of the DRESS syndrome. Int J Clin Pract 2005; 59: 988-91. (21 year old woman developed fever and rash 2 months after starting carbamazepine [bilirubin 2.4 mg/dL, ALT 1001 U/L, Alk P 148 U/L, protime 31 seconds, eosinophils 900/uL], with subsequent worsening, hepatic failure and death). 16033627
Muñoz-Cerón JF, Nariño-González D, Uribe-Granja M. [Carbamazepine-associated pseudolymphoma] Rev Neurol 2006; 43: 700-2. Spanish. 17133333
Skopp G, Schmitt HP, Pedal I. [Fulminant liver failure in a patient on carbamazepine and levetiracetam treatment associated with status epilepticus]. Arch Kriminol 2006; 217: 161-75. German. (22 year old woman on long term carbamazepine developed acute liver failure after a period of status epilepticus and mild but prolonged hypotension; autopsy was more compatible with ischemic hepatitis than drug induced liver injury, and no routine liver tests [bilirubin, ALT, Alk P, LDH, CPK, protime] provided). 16910300
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (In WHO database of fatal adverse drug reactions from 1968-2003, 4690 reports of drug induced liver fatality: phenytoin was the only anticonvulsant within the 19 most common causes, ranking 12th [57 cases]). 16054882
Lonjou C, Thomas L, Borot N, Ledger N, de Toma C, LeLouet H, Graf E, et al; RegiSCAR Group. A marker for Stevens-Johnson syndrome ...: ethnicity matters. Pharmacogenomics J 2006; 6: 265-8. (Preliminary results of testing 12 European patients with Stevens Johnson syndrome due to carbamazepine among whom only 4 [25%] had HLA-B*1502, all of whom were of Asian background suggesting that the association may not apply to European subjects). 16415921
Man CB, Kwan P, Baum L, Yu E, Lau KM, Cheng AS, Ng MH. Association between HLA-B*1502 allele and antiepileptic drug-induced cutaneous reactions in Han Chinese. Epilepsia 2007; 48: 1015-8. (Study of 24 patients with cutaneous reactions to anticonvulsant medications from Hong Kong found that 4 of 4 with carbamazepine induced Stevens Johnson syndrome or toxic epidermal necrolysis had HLA-B*1502, but none of 4 with macular papular dermatitis from the same drug). 17509004
Tohyama M, Hashimoto K, Yasukawa M, Kimura H, Horikawa T, Nakajima K, Urano Y, et al. Association of human herpesvirus 6 reactivation with the flaring and severity of drug-induced hypersensitivity syndrome. Br J Dermatol 2007; 157: 934-40. (Anti-HHV-6 testing of 100 patients with drug induced hypersensitivity syndrome [34% with hepatitis] found rise in IgG levels in 62 patients, largely in more severe cases; HHV-6 DNA detected in 18; drugs implicated included carbamazepine, phenobarbital, phenytoin, allopurinol, sulfasalazine and mexiletine). 17854362
Gawlikowski T, Hydzik P. [Carbamazepine hepatoxicity—a case report] Przegl Lek 2007; 64: 318-9. Polish. 17724898
Ueda K, Ishitsu T, Seo T, Ueda N, Murata T, Hori M, Nakagawa K. Glutathione S-transferase M1 null genotype as a risk factor for carbamazepine-induced mild hepatotoxicity. Pharmacogenomics 2007; 8: 435-42. (Genetic polymorphisms of glutathione S-transferase [GST] tested in 192 Japanese patients with epilepsy found correlations of GSTM1 with ALT levels; not with hypersensitivity syndrome or clinically apparent cases of hepatotoxicity). 17465707
Réaud S, Oberti F, Leclech C, Calès P. [Hepatotoxicity of carbamazepine: a case of "DRESS syndrome"]. Gastroenterol Clin Biol 2007; 31: 205-6. French. (42 year old man developed rash 4 weeks after starting carbamazepine with desquamation, pruritis, adenopathy, fever and facial edema [bilirubin 0.7 mg/dL, ALT 9 times ULN, Alk P 3 times ULN, no eosinophilia], resolving within 2 weeks of stopping). 17347634
Fsadni C, Fsadni P, Piscopo T, Mallia Azzopardi C. Carbamazepine-induced drug reaction with eosinophilia and systemic symptoms syndrome in a 35-year-old man with epilepsy. Clin Neuropharmacol 2008; 31: 295-8. (35 year old man developed fever, rash and jaundice 2 months after adding carbamazepine to phenytoin therapy [bilirubin 15.4 mg/dL, ALT 252 U/L, Alk P 374 U/L, no eosinophilia], worsening for 2 weeks while carbamazepine continued before starting recovery on corticosteroids). 18836349
Ganeva M, Gancheva T, Lazarova R, Troeva J, Baldaranov I, Vassilev I, Hristakieva E, Tzaneva V. Carbamazepine-induced drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome: report of four cases and brief review. Int J Dermatol 2008; 47: 853-60. (Review of carbamazepine induced hypersensitivity syndromes and 4 case reports; onset after 3-4 weeks of starting carbamazepine with rash, fever and eosinophilia, 2 with liver involvement and 1 with jaundice, all treated with corticosteroids and all resolved without recurrence, 3 taking valproate). 18717872
Lonjou C, Borot N, Sekula P, Ledger N, Thomas L, Halevy S, Naldi L, et al; RegiSCAR study group. A European study of HLA-B in Stevens-Johnson syndrome and toxic epidermal necrolysis related to five high-risk drugs. Pharmacogenet Genomics 2008; 18: 99-107. (HLA-B genotyping of a cohort of patients with Stevens Johnson syndrome [SJS] and toxic epidermal necrolysis [TEN] due to medications found an association of B*5801 with SJS/TEN due to allopurinol in all 4 non-Europeans [100%], but a lower proportion of 27 Europeans [55%], whereas B*1502 was linked to SJS/TEN due to carbamazepine only in non-Europeans). 18192896
Locharernkul C, Loplumlert J, Limotai C, Korkij W, Desudchit T, Tongkobpetch S, Kangwanshiratada O, et al. Carbamazepine and phenytoin induced Stevens-Johnson syndrome is associated with HLA-B*1502 allele in Thai population. Epilepsia 2008; 49: 2087-91. (Testing for HLA-B*1502 in 81 Thai patients on anticonvulsants found a 100% association of this allele with SJS due to carbamazepine [6 of 6 patients] and phenytoin [4 of 4], with a rate of ~18% among tolerant patients and a similar rate in those with macular papular rashes). 18637831
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, carbamazepine was implicated in only one case). 18955056
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scan 2008; 118: 281-90. (Review of all anticonvulsant induced liver injury including discussion of 60 cases of carbamazepine hepatotoxicity which is usually a part of hypersensitivity syndrome, typically mixed enzyme pattern, 27% with eosinophilia, mean onset at 5 weeks, 17% mortality which is more common in children and with hepatocellular pattern of enzymes and with longer latency to onset). 18341684
Crespo Pérez L, Moreira Vicente V, Cano Ruiz A, Gobernado Serrano JM, Cobo Ibañez N, Milicua Salamero JM. [Anticonvulsant hypersensitivity syndrome: an entity to be remembered]. Gastroenterol Hepatol 2009; 32: 687-92. Spanish. (15 year old girl developed developed fever and rash several weeks after starting carbamazepine). 19732994
Adams EN, Marks A, Lizer MH. Carbamazepine-induced hyperammonemia. Am J Health Syst Pharm 2009; 66: 1468-70. (26 year old man with traumatic brain disorder developed aggressive behavior 3 weeks after starting carbamazepine [ammonia 127 µg/dL, liver tests normal], which resolved with stopping the drug and use of lactulose, later found to have a history of similar hyperammonemia from a previous therapy with carbamazepine and another episode after valproate). 19667003
Eshki M, Allanore L, Musette P, Milpied B, Grange A, Guillaume JC, Chosidow O, et al. Twelve-year analysis of severe cases of drug reaction with eosinophilia and systemic symptoms: a cause of unpredictable multiorgan failure. Arch Dermatol 2009; 145: 67-72. (Among 15 patients with severe DRESS from France, average onset was within 18 days, 2/3rds were women and causes included allopurinol [4], minocycline [3], sulfonamides [3] and anticonvulsants [3]; one each for phenobarbital, phenytoin and lamotrigine; about half had liver involvement). 19153346
Aouam K, Ben Romdhane F, Loussaief C, Salem R, Toumi A, Belhadjali H, Chaabane A, et al. Hypersensitivity syndrome induced by anticonvulsants: possible cross-reactivity between carbamazepine and lamotrigine. J Clin Pharmacol 2009; 49: 1488-91. (14 year old boy developed facial edema and fever 6 weeks after starting carbamazepine [bilirubin not given, ALT 193 U/L, eosinophils 15%], which resolved with stopping, and months later he developed fever, rash and pneumonitis 7 weeks after starting lamotrigine [ALT 154 U/L, eosinophils 12%], resolving upon stopping). 19723672
Franciotta D, Kwan P, Perucca E. Genetic basis for idiosyncratic reactions to antiepileptic drugs. Curr Opin Neurol 2009; 22: 144-9. (Review of the genetic associations with hypersensitivity reactions to anticonvulsant medications; closest association has been with HLA-B*1502 and Stevens Johnson syndrome after aromatic anticonvulsants). 19262378
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contains 9036 hepatic adverse drug reactions in children, carbamazepine accounting for 140 cases [1.5% of total] for an adjusted odds ratio of 3.6).21039766
Tassaneeyakul W, Tiamkao S, Jantararoungtong T, Chen P, Lin SY, Chen WH, Konyoung P, et al. Association between HLA-B*1502 and carbamazepine-induced severe cutaneous adverse drug reactions in a Thai population. Epilepsia 2010; 51: 926-30. (Among 42 Thai patients with carbamazepine induced SJS/TEN, 37 [88%] had the HLA-B*1502 allele compared to 12% of tolerant controls, yielding and a positive predictive value of 1.9% and negative value of 99.9%). 20345939
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 3 attributed to carbamazepine). 20949552
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India: 9 [2.9%] were attributed to carbamazepine). 20648003
Kaniwa N, Saito Y, Aihara M, Matsunaga K, Tohkin M, Kurose K, Furuya H, et al; JSAR research group. HLA-B*1511 is a risk factor for carbamazepine-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in Japanese patients. Epilepsia 2010; 51: 2461-5. (Among 14 Japanese patients with SJS/TEN due to carbamazepine, none had the HLA-B*1502 allele but 4 [29%] had B*1511, a member of the same superfamily). 21204807
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; for the Drug-Induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN Prospective Study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with drug induced liver injury enrolled in a prospective US database between 2004 and 2008, 8 were due to anticonvulsants [lamotrigine in 3, valproate in 3, phenytoin in 1 and carbamazepine in 1], none of which were fatal or led to chronic injury). 21788760
Gerull R, Nelle M, Schaible T. Toxic epidermal necrolysis and Stevens-Johnson syndrome: a review. Crit Care Med 2011; 39: 1521-32. (Review of SJS and TEN which represent a spectrum of severe inflammatory skin reactions often due to medications including NSAIDs, carbamazepine, phenytoin, allpurinol, phenobarbital and valproate; no specific therapy has been shown to be beneficial). 21358399
McCormack M, Alfirevic A, Bourgeois S, Farrell JJ, Kasperavičiūtė D, Carrington M, Sills GJ, et al. HLA-A*3101 and carbamazepine-induced hypersensitivity reactions in Europeans. N Engl J Med 2011; 364: 1134-43. (Genome wide association study on 43 Europeans with carbamazepine hypersensitivity syndromes identified HLA A*3101 in 27% of cases compared to 4% of controls). 21428769
Chen P, Lin JJ, Lu CS, Ong CT, Hsieh PF, Yang CC, Tai CT, et al; Taiwan SJS Consortium. Carbamazepine-induced toxic effects and HLA-B*1502 screening in Taiwan. N Engl J Med 2011; 364: 1126-33. (Prospective assessment of effects of HLA screening among 4855 Taiwanese adults about to start carbamazepine; those with B*1502 were advised to take another agent; in follow up, there were no cases of SJS/TEN, whereas 10 [0.23%] were expected). 21428768
Harr T, French LE. Stevens-Johnson syndrome and toxic epidermal necrolysis. Chem Immunol Allergy 2012; 97: 149-66. (Review of clinical features, pathogenesis, genetics, scoring systems, management and outcome of SJS/TEN). 22613860
Chung WH, Hung SI. Recent advances in the genetics and immunology of Stevens-Johnson syndrome and toxic epidermal necrosis. J Dermatol Sci 2012; 66: 190-6. (Review of genetics and immunology of SJS/TEN discusses the association of carbamazepine induced SJS with HLA-B*1502 in Asians and HLA-A*3101 in Europeans and the interactions of drug, peptide, HLA alleles and T cell receptors). 22541332
Yip VL, Marson AG, Jorgensen AL, Pirmohamed M, Alfirevic A. HLA genotype and carbamazepine-induced cutaneous adverse drug reactions: a systematic review. Clin Pharmacol Ther 2012; 92: 757-65. (Systematic review of literature on HLA genotypes and cutaneous adverse reactions to carbamazepine found 23 studies on a total of 690 patients and 1585 "tolerant" controls which reported that 96% of Southeast Asian SJS/TEN cases vs 11% of controls had HLA-B*1502 allele, but association not found in Japan, Korea or Europe where A*3101 which linked to all hypersensitivity reactions in Koreans, Japanese and Europeans). 23132554
McCormack M, Urban TJ, Shianna KV, Walley N, Pandolfo M, Depondt C, Chaila E, et al. Genome-wide mapping for clinically relevant predictors of lamotrigine- and phenytoin-induced hypersensitivity reactions. Pharmacogenomics 2012; 13: 399-405. (Genome wide association studies failed to identify any significant variation [including HLA-A*3101, previously associated with carbamazepine reactions in Europeans: McCormack 2011] associated with hypersensitivity to lamotrigine [n=46] or phenytoin [n=44]). 22379998
Patel PP, Gandhi AM, Desai CK, Desai MK, Dikshit RK. An analysis of drug induced Stevens-Johnson syndrome. Indian J Med Res 2012; 136: 1051-3. (59 cases of drug induced Stevens Johnson syndrome were seen at a single referral center in India between 2005-2010, 25% in children, arising 1-39 days after starting drug, major causes being phenytoin [18] and nevirapine [13], 4 were attributed to carbamazepine). 23391805
Knowles SR, Dewhurst N, Shear NH. Anticonvulsant hypersensitivity syndrome: an update. Expert Opin Drug Saf 2012; 11: 767-78. (DRESS syndrome is marked by triad of fever, rash and internal organ involvement, usually liver; carbamazepine is a well known cause). 2794330
Neuman MG, Cohen L, Nanau RM, Hwang PA. Genetic and immune predictors for hypersensitivity syndrome to antiepileptic drugs. Transl Res 2012; 159: 397-406. (Review of hypersensitivity reactions to antiepileptic agents including carbamazepine and lymphotycte toxicity assays). 22500513
Kim HI, Kim SW, Park GY, Kwon EG, Kim HH, Jeong JY, Chang HH, Lee JM, Kim NS. Causes and treatment outcomes of Stevens-Johnson syndrome and toxic epidermal necrolysis in 82 adult patients. Korean J Intern Med 2012; 27(2): 203-10. (Analysis of 82 patients with SJS/TEN seen between 2001 and 2011 at a Korean referral center found 52% due to drugs, 7 due to carbamazepine [8%], the single most common agent; mortality was 10%). 22707893
Sethuraman G, Sharma VK, Pahwa P, Khetan P. Causative Drugs and Clinical Outcome in Stevens Johnson Syndrome (SJS), Toxic Epidermal Necrolysis (TEN), and SJS-TEN Overlap in Children. Indian J Dermatol 2012; 57: 199-200. (Analysis of 20 children with SJS/TEN seen at an Indian referral center between 2007 and 2010; 15 were attributed to medications including 3 to carbamazepine: mortality rate 15%). 22707771
Kannenberg SM, Jordaan HF, Koegelenberg CF, Von Groote-Bidlingmaier F, Visser WI. Toxic epidermal necrolysis and Stevens-Johnson syndrome in South Africa: a 3-year prospective study. QJM 2012; 105: 839-46. (Analysis of 75 adults patients with SJS/TEN seen between 2008 and 2011 at a referral center in South Africa, 59 [79%] were HIV positive and the major causes were drugs [96%] including TMP/SMZ 24%, nevirapine [30%], tuberculosis medications [20%] and anticonvulsants [16%]; one fatal case was due to carbamazepine). 22543685
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, Park JW, Hong CS. Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci 2012; 27: 268-73. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 6 [1.1%] attributed to carbamazepine). 22379337
Wei CY, Chung WH, Huang HW, Chen YT, Hung SI. Direct interaction between HLA-B and carbamazepine activates T cells in patients with Stevens-Johnson syndrome. J Allergy Clin Immunol 2012; 129: 1562-9. (Cytotoxic T cells responding to carbamazepine were found in all 20 patients with a history of carbamazepine related SJS/TEN but in none of 4 tolerant controls, the HLA-B*1502 binding requiring endogenous peptides, but without processing of carbamazepine). 22322005
Sawicki J, Ellis AK. Stevens-Johnson syndrome: a review of 14 adult cases with one fatal outcome. Ann Allergy Asthma Immunol 2013; 110: 207-9. (Review of 14 cases of SJS seen at a single Canadian hospital between 2002 and 2010, 2 had minor enyzme elevations, but none were jaundiced; causes included phenytoin, carbamazepine, lamotrigine, sulfonamides and allopurinol). 23548536
Cheung YK, Cheng SH, Chan EJ, Lo SV, Ng MH, Kwan P. HLA-B alleles associated with severe cutaneous reactions to antiepileptic drugs in Han Chinese. Epilepsia 2013 May 20. [Epub ahead of print] (HLA-B*1502 was found in 24 of 26 [92%] Chinese patients with carbamazepine related, but only 2 of 6 [33%] with lamotrigine related SJS versus 12% of controls). 23692434
Kaniwa N, Saito Y. Pharmacogenomics of severe cutaneous adverse reactions and drug-induced liver injury. J Hum Genet. 2013 May 2. [Epub ahead of print] (Review of genetic associations with severe skin and liver injury from drugs, focusing upon allopinol [B*5801], abacavir and flucloxacillin [B*5701] an dlapatinib [DQA1*02:01]; the association of B*1502 with carbamazepine induced SJS has not been extended to carbamazepine induced liver injury). 23635947
Sekula P, Dunant A, Mockenhaupt M, Naldi L, Bouwes Bavinck JN, Halevy S, Kardaun S, Sidoroff A, Liss Y, Schumacher M, Roujeau JC. Comprehensive survival analysis of a cohort of patients with Stevens-Johnson syndrome and toxic epidermal necrolysis. J Invest Dermatol. 2013; 133: 1197-204. (Analysis of mortality rates in 460 patients with SJS/TEN [67% due to drugs] in a European observational database found that age, severity, underlying malignancy and renal or hepatic involvement correlated with poor survival; overall mortality at one year being 24% for SJS, 43% for overlap and 49% for TEN cases). 23389396
Lee T, Lee YS, Yoon SY, Kim S, Bae YJ, Kwon HS, Cho YS, Moon HB, Kim TB. Characteristics of liver injury in drug-induced systemic hypersensitivity reactions. J Am Acad Dermatol 2013 Apr 27. [Epub ahead of print] (Analysis of 136 patients with hypersensitivity reactions to drugs seen at a single referral center in Korea found liver involvement in 61 [45%], including 11 with SJS/TEN, 29 with DRESS and 17 with rash only; 20 cases were attributed to anticonvulsants). 23632341
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of drugs of choice for epilepsy; mentions that the adverse effects of carbamazepine include acute hepatitis and Stevens Johnson syndrome). 23348233
Teng P, Tan B. Carbamazepine-induced DRESS syndrome in a child: rapid response to pulsed corticosteroids. Dermatol Online J 2013; 19: 18170. (14 year old boy developed fever and rash 2 weeks after starting carbamazepine [peak bilirubin ~17 mg/dL, ALT 1420 U/L, Alk P 610 U/L], resolving with corticosteroid therapy within 3 weeks of stopping). 24011271
Planjar-Prvan M, Bielen A, Sruk A, Marusić M, Bielen I. Acute oxcarbazepine-induced hepatotoxicity in a patient susceptible to developing drug-induced liver injury. Coll Antropol 2013; 37: 281-4. (Ordered). 23697284
Tangamornsuksan W, Chaiyakunapruk N, Somkrua R, Lohitnavy M, Tassaneeyakul W. Relationship between the HLA-B*1502 allele and carbamazepine-induced Stevens-Johnson syndrome and toxic epidermal necrolysis: a systematic review and meta-analysis. JAMA Dermatol 2013; 149: 1025-32. (Systematic review of the literature on the association of carbamazepine related SJS/TEN with HLA-B*1502 found a strong correlation across 16 studies with 227 cases [87% with the allele] and 602 tolerant controls [9%], with association in Han Chinese, Malaysian, Thai and Indian populations but not in Japanese or Europeans). 23884208
He XJ, Jian LY, He XL, Wu Y, Xu YY, Sun XJ, Miao LY, Zhao LM. Association between the HLA-B*15:02 allele and carbamazepine-induced Stevens-Johnson syndrome/toxic epidermal necrolysis in Han individuals of northeastern China. Pharmacol Rep 2013; 65: 1256-62. (HLA-B*1502 was found in 8 of 35 [23%] Northern Chinese patients with carbamazepine related SJS/TEN compared to 2 of 125 [1.6%] of controls, a lower association than found in Southern China [Taiwan]). 24399721
Aggarwal R, Sharma M, Modi M, Garg VK, Salaria M. HLA-B∗ 1502 is associated with carbamazepine induced Stevens-Johnson syndrome in North Indian population. Hum Immunol 2014; 75: 1120-2. (HLA-B*1502 alleles were identified in 2 of 9 Indian patients with carbamazepine associated SJS, but in none of 8 with phenytoin associated SJS and none of 50 tolerant controls). 25305458
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]). 24552865
Mehta M, Shah J, Khakhkhar T, Shah R, Hemavathi KG. Anticonvulsant hypersensitivity syndrome associated with carbamazepine administration: Case series. J Pharmacol Pharmacother 2014; 5: 59-62. (Three Indian men, ages 30, 41 and 50 years, developed rash, fever and serum enzyme elevations 7-10 days after starting carbamazepine [ALT 50-66 U/L, bilirubin normal], resolving on stopping drug). 24554914
Yip VL, Alfirevic A, Pirmohamed M. Genetics of immune-mediated adverse drug reactions: a comprehensive and clinical review. Clin Rev Allergy Immunol 2015; 48: 165-75. (Review of the genetics of immune mediated drug reactions focusing upon skin injury from abacavir [HLA-B*57:01], carbamazepine [B*15:02, A*31:01], and allopurinol [B*58:01] and hepatotoxicity from amoxicillin/ clavulanate [several], flucloxacillin [B*57:01], ximelagatran, lumiracoxib, lapatinib, ticlopidine and nevirapine). 24777842
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 cases [0.5%] were attributed to carbamazepine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Carbamazepine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(carbamazepine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/01%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Carbamazepine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=carbamazepine)